# Ramipril

## OVERVIEW

### Introduction

Ramipril is an angiotensin-converting enzyme (ACE) inhibitor used in the therapy of hypertension and heart failure. Ramipril is associated with a low rate of transient serum aminotransferase elevations and has been linked to rare instances of acute liver injury.

### Background

Ramipril (ra' mi pril) is an ACE inhibitor widely used in the therapy of hypertension, heart failure and for reduction in risk of myocardial infarction and stroke. Like other ACE inhibitors, ramipril inhibits the conversion of angiotensin I, a relatively inactive molecule, to angiotensin II which is the major mediator of vasoconstriction and volume expansion induced by the renin-angiotensin system. Other enzymes besides that which converts angiotensin I to II may also be inhibited, which may account for some of the side effects of ramipril and other ACE inhibitors. Ramipril was approved for use in the United States in 1991 and is available in 1.25, 2.5, 5 and 10 mg capsules or tablets in generic forms and under the trade name Altace. In adults, ramipril is usually started in a dose of 2.5 mg daily and then adjusted based upon blood pressure response and tolerance to 10 to 20 mg daily. It is typically used long term. Common side effects include dizziness, fatigue, headache, cough, gastrointestinal upset and skin rash.

### Hepatotoxicity

Ramipril, like other ACE inhibitors, has been associated with a low rate of serum aminotransferase elevations (<2%) that, in controlled trials, was no higher than with placebo therapy. These elevations were transient and rarely required dose modification. Rare instances of clinically apparent acute liver injury have been reported with ramipril therapy. The onset is usually within 2 to 12 weeks of starting therapy and the serum enzyme pattern is typically cholestatic (Case 1). In some instances, cholestasis has been prolonged and relapsing and associated with persistent elevations in serum alkaline phosphatase, suggestive of vanishing bile duct syndrome. Immunoallergic manifestations (rash, fever, eosinophilia) are infrequent and most patients do not develop autoantibodies. Rare instances of ramipril injury with a hepatocellular pattern and cases with a long latency (one or more years) have been described as well. Likelihood score:

Likelihood score: C (probable rare cause of clinically apparent liver injury).

### Mechanism of Injury

The cause of the minor serum aminotransferase elevations associated with ramipril therapy is not known. The clinically apparent acute liver injury due to ramipril is idiosyncratic and is likely due to a reaction to a minor metabolite. Ramipril is hydrolyzed in the liver to its active carboxylic metabolite ramiprilat, but undergoes little further hepatic metabolism.

### Outcome and Management

Only a few cases of ramipril associated liver injury have been reported, but the rare instances that have been published have resembled typical ACE inhibitor related hepatic injury. Most instances of acute liver injury related to ACE inhibitors have been self limited, but severe cases of cholestatic hepatitis can result in prolonged jaundice and vanishing bile duct syndrome. Patients with severe ramipril induced acute liver injury or hypersensitivity should avoid use of other ACE inhibitors, although cross sensitivity to liver injury among the members of this class of agents has not always been shown.

References to the safety and potential hepatotoxicity of ramipril are given in the Overview section on the Angiotensin-Converting Enzyme (ACE) Inhibitors.

Drug Class: Antihypertensive Agents, Angiotensin-Converting Enzyme Inhibitors

## CASE REPORT

### Case 1. Acute hepatitis due to ramipril.

[Modified from: Yeung E, Wong FS, Wanless IR, Shiota K, Guindi M, Joshi S, Gardiner G. Ramipril-associated hepatotoxicity. Arch Pathol Lab Med 2003; 127: 1493-7. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/14567716)]

A 51 year old Jamaican born man was started on ramipril and atorvastatin after an acute myocardial infarction and 2 weeks later developed anorexia, jaundice and pruritus. He had a history of tuberculosis, recurrent kidney stones and parotid gland infections, and type 2 diabetes. His only other medications at the time were insulin and aspirin, and he specifically denied use of over-the-counter and herbal preparations. He had no history of liver disease, alcohol abuse or risk factors for viral hepatitis. Laboratory testing showed a total bilirubin of 8.4 mg/dL and alkaline phosphatase of 112 U/L (Table). Both atorvastatin and ramipril were discontinued, but he did not improve and subsequently developed diarrhea and weight loss. Three months after onset he was reevaluated. Tests for hepatitis A, B and C were negative as were autoantibodies. Endoscopic retrograde cholangiopancreatography showed no evidence of biliary obstruction. A liver biopsy showed marked cholestasis, bile duct injury and increased fibrosis compatible with early cirrhosis. He was treated with ursodiol but continued to have jaundice. A year after onset of injury, he was found to have ascites and esophageal varices. Two years later he was still jaundiced. He was listed for liver transplantation but returned to his country of origin and was lost to follow up.

#### Key Points

Medication: | Ramipril (2.5 mg daily)
Pattern: | Cholestatic
Severity: | 4+ (prolonged jaundice)
Latency: | 4 weeks
Recovery: | None
Other medications: | Atorvastatin, insulin, aspirin

#### Laboratory Values

Months After Starting | Months After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Other
1 | 0 | | 112 | 8.4 | Anorexia, pruritus
4 | 2.5 | 103 | 957 | 15.5 | INR=1.22, liver biopsy
15 | 4 | 71 | 939 | 11.8 | INR=1.3
Normal Values | | <45 | <125 | <1.2

#### Comment

Case 1 from a published series of 3 patients with suspected ramipril induced liver injury from an experienced group of hepatologists from Toronto. The latency period of 4 weeks and general clinical presentation as cholestatic hepatitis is typical of ACE inhibitor related drug induced liver injury. While few cases have been linked to ramipril, the lack of other explanations for the liver injury in the three cases and improvements on stopping ramipril in the other two cases were highly suggestive of its role. Patient 1 had persistence of jaundice after the initial episode and a subsequent course that was suggestive of vanishing bile duct syndrome.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Ramipril – Generic, Altace®

DRUG CLASS

Angiotensin-Converting Enzyme Inhibitors

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Ramipril)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Ramipril | 87333-19-5 | C23-H32-N2-O5 | Ramipril Chemical Structure

## OTHER REFERENCE LINKS

1. Recent References on Ramipril: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Ramipril/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Ramipril: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Ramipril)